# Degarelix

## OVERVIEW

### Introduction

Degarelix is a parenterally administered, gonadotropin releasing hormone (GnRH) antagonist that effectively blocks androgen production and is used to treat advanced prostate cancer. Degarelix therapy is associated with serum enzyme elevations during therapy, but has yet to be linked to instances of clinically apparent acute liver injury.

### Background

Degarelix (deg" a rel' ix) is a synthetic decapeptide antagonist of gonadotropin releasing hormone (GnRH) that blocks GnRH stimulation of luteinizing hormone (LH) and follicular stimulating hormone (FSH) production by the pituitary gland, thereby decreasing the synthesis of testosterone by the testes in men and estrogen by the ovaries in women. Degarelix has been found to be palliative in advanced prostate cancer with equivalent efficacy to the GnRH agonists, such as leuprolide and goserelin. Because degarelix is an antagonist of GnRH, it does not cause the initial increase in testosterone synthesis that occurs with use of GnRH agonists. Degarelix was approved for use in the United States in 2008, and current indications are limited to therapy of advanced prostate cancer. GnRH analogues have also been used off label for precocious puberty, infertility, and as a part of gender affirming therapy. Degarelix is available under the brand name Firmagon as a powder for reconstitution in 80 and 120 mg vials. The typical dose is 240 mg initially, with maintenance doses of 80 mg every 28 days. Common side effects include injection site reactions and symptoms typical of hypogonadism such as hot flashes, decreased libido, erectile dysfunction, nausea, diarrhea, weight gain and fluid retention. Potential severe adverse reactions include acute hypersensitivity reactions.

### Hepatotoxicity

Degarelix therapy has been associated with serum enzyme elevations in up to one-third of patients. The elevations, however, are generally mild and self-limited, resolving even without dose adjustment. ALT values above 3 times the ULN occur in less than 1% of patients. Occasional patients require drug discontinuation because of serum enzyme elevations, but no instances of liver injury with jaundice or clinically apparent acute liver injury were reported in the initial clinical trials of degarelix. Since its approval and more widescale use, there have been no published reports of clinically apparent liver injury attributed to degarelix, although its general use has been limited.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

### Mechanism of Injury

The mechanism by which degarelix might cause liver injury is unknown. It is a decapeptide and is metabolized by many tissues to individual amino acids. It has no effect on cytochrome P450 activity and has not been implicated in drug-drug interactions.

### Outcome and Management

While serum aminotransferase elevations during degarelix therapy are common, they rarely require dose adjustment or drug discontinuation. Routine monitoring of liver tests is not recommended except in patients with known, preexisting liver disease. There is no evidence of cross sensitivity to liver injury among the various GnRH analogues.

Drug Class: Antineoplastic Agents, GnRH Analogues

Other Drugs in the Subclass, GnRH Analogues: Goserelin, Histrelin, Leuprolide, Relugolix, Triptorelin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Degarelix – Firmagon®

DRUG CLASS

Antineoplastic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Degarelix)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NO. | MOLECULAR FORMULA | STRUCTURE
Degarelix | 214766-78-6 | C82-H103-Cl-N18-O16

## ANNOTATED BIBLIOGRAPHY

References updated: 28 May 2023

Abbreviations: FSH, follicle stimulating hormone; GnRH, gonadotropin releasing hormone; LH, luteinizing hormone; PSA, prostate specific antigen.

Zimmerman HJ. Hepatotoxic effects of oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 699. (Expert review of hepatotoxicity published in 1999; the GnRH analogues such as degarelix are not discussed).
Chitturi S, Farrell GC. Estrogen receptor antagonists. Adverse effects of hormones and hormone antagonists on the liver. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 610-2. (Review of hepatotoxicity of hormonal products, does not discuss the GnRH analogues such as leuprolide, goserelin and degarelix).
Levin ER, Vitek WS, Hammes SR. Estrogens, progestins, and the female reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 803-31. (Textbook of pharmacology and therapeutics).
Snyder PJ. Androgens and the male reproductive tract. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 833-43. (Textbook of pharmacology and therapeutics).
Isaacs C, Wellstein A, Riegel AT. Hormones and related agents in the therapy of cancer. In, Brunton LL, Halal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1237-47. (Textbook of pharmacology and therapeutics).
Van Poppel H, Tombal B, de la Rosette JJ, Persson BE, Jensen JK, Kold Olesen T. (2008). Degarelix: a novel gonadotropin-releasing hormone (GnRH) receptor blocker--results from a 1-yr, multicentre, randomised, phase 2 dosage-finding study in the treatment of prostate cancer. Eur Urol. (Among 187 men with advanced prostate cancer treated with degarelix at different initial [200 or 240 mg] and maintenance [80, 120 or 160 mg monthly] doses for one year, testosterone and PSA levels fell rapidly without an initial surge and remained suppressed; ALT levels were above 3 times ULN in 10 patients [5%] but were transient and resolved despite continuing drug).
Whelan P. (2008). Editorial comment on: Degarelix: a novel gonadotropin-releasing hormone (GnRH) receptor blocker-results from a 1-yr, multicentre, randomised, phase 2 dose-finding study in the treatment of prostate cancer. Eur Urol. (Editorial in response to Van Poppel [2008], questioning whether degarelix is more effective and as safe as surgical castration or GnRH agonist therapy).
Gittelman M, Pommerville PJ, Persson BE, Jensen JK, Olesen TK, Degarelix Study Group. (2008). A 1-year, open label, randomized phase II dose finding study of degarelix for the treatment of prostate cancer in North America. J Urol. (Among 127 patients with advanced prostate cancer treated with degarelix for 1 year, testosterone levels were rapidly suppressed without an initial surge; ALT elevations occurred in 16% and 33% of subjects, but all elevations were less than 3 times ULN and resolved without dose adjustment or discontinuation).
Klotz L, Boccon-Gibod L, Shore ND, Andreou C, Persson BE, Cantor P, Jensen JK, Olesen TK, Schrö FH. (2008). The efficacy and safety of degarelix: a 12-month, comparative, randomized, open-label, parallel-group phase III study in patients with prostate cancer. BJU Int. (Among 610 patients with advanced prostate cancer treated with degarelix or leuprolide, common adverse events included injection site reactions [40% vs <1%], hot flashes [26% vs 21%], weight gain [10% vs 12%], and ALT elevations [9% vs 5%]; one patient on degarelix stopped therapy because of liver test abnormalities, but there were no instances of clinically apparent liver injury or liver injury with jaundice).
Frampton JE, Lyseng-Williamson KA. (2009). Degarelix. Drugs. (Review of the structure, mechanism of action, pharmacology, clinical efficacy and safety of degarelix mentions that it is "generally well tolerated", with adverse events largely due to subcutaneous injections and androgen deprivation and that ALT elevations above 3 times the ULN occurred in 7% of degarelix- vs 6% of leuprolide-treated patients).
(2009). Degarelix (firmagon) for prostate cancer. Med Lett Drugs Ther. (Concise review of the mechanism of action, rationale, clinical efficacy, safety and costs of degarelix as therapy for prostate cancer shortly after its approval in the US; mentions that "increases in hepatic transaminases" are common adverse events).
Boccon-Gibod L, van der Meulen E, Persson BE. (2011). An update on the use of gonadotropin-releasing hormone antagonists in prostate cancer. Ther Adv Urol. (GnRH antagonists such as degarelix have similar efficacy to GnRH agonists in therapy of prostate cancer but have a more rapid onset of action and do not cause the initial testosterone surge that occurs with the agonists, which can be particularly troublesome in patients with a large tumor burden).
Van Poppel H, Klotz L. (2012). Gonadotropin-releasing hormone: an update review of the antagonists versus agonists. Int J Urol. (Review of androgen deprivation therapy for prostate cancer using GnRH agonists and antagonists, stressing the more rapid onset of action and similar if not better safety profile of GnRH antagonists).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to degarelix or other GnRH analogues).
Crawford ED, Shore ND, Moul JW, Tombal B, Schrö FH, Miller K, Boccon-Gibod L, et al. (2014). Long-term tolerability and efficacy of degarelix: 5-year results from a phase III extension trial with a 1-arm crossover from leuprolide to degarelix. Urology. (Among participants in the initial controlled trial of degarelix vs leuprolide [Klotz 2008], 544 were then treated with degarelix for up to 5 years and generally continued to have potent suppression of testosterone and PSA levels; ALT elevations occurred in 6% of patients, but there was no mention of cases of clinically apparent liver injury).
Carter NJ, Keam SJ. (2014). Degarelix: a review of its use in patients with prostate cancer. Drugs. (Review of mechanism of action, clinical efficacy and safety of degarelix for advanced prostate cancer mentions that liver test abnormalities occur but are usually mild and transient and that ALT elevations above 3 times ULN occurred in less than 1% of treated patients).
Miller K, Simson G, Goble S, Persson BE. (2015). Efficacy of degarelix in prostate cancer patients following failure on luteinizing hormone-releasing hormone agonist treatment: results from an open-label, multicentre, uncontrolled, phase II trial(CS27). Ther Adv Urol. (Among 37 patients with advanced prostate cancer who had failed therapy with a GnRH agonist, switching to degarelix for up to 1 year yielded a low rate of response [8%] with poor tolerance and a high dropout rate; changes in clinical chemistry results were "small, with no consistent trends").
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to GnRH analogues such as degarelix).
Dearnaley DP, Saltzstein DR, Sylvester JE, Karsh L, Mehlhaff BA, Pieczonka C, Bailen JL, et al. (2020). The oral gonadotropin-releasing hormone receptor antagonist relugolix as neoadjuvant/adjuvant androgen deprivation therapy to external beam radiotherapy in patients with localised intermediate-risk prostate cancer: a randomised, open-label, parallel-group phase 2 trial. Eur Urol. (Among 103 men with prostate cancer receiving radiotherapy who were treated with androgen deprivation therapy with relugolix [120 mg tablets daily] or degarelix [80 mg injections monthly], suppression of testosterone and PSA levels were similar in the two groups and adverse events were slightly fewer with relugolix [86% vs 97%], ALT elevations arising in none vs 13% but none were greater than 5 times ULN).
Sawazaki H, Kitamura Y, Yagi K, Arai Y. (2020). Impact of androgen deprivation therapy on non-alcoholic fatty liver disease in patients with prostate cancer: a CT evaluation. Urol Int. (Among 77 patients with prostate cancer treated with androgen deprivation therapy [32 with leuprolide and 45 degarelix] for 6 months, computerized tomography demonstrated development of fatty liver in 7 patients but little change in body weight).
Wallach JD, Deng Y, McCoy RG, Dhruva SS, Herrin J, Berkowitz A, Polley EC, et al. (2021). Real-world cardiovascular outcomes associated with degarelix vs leuprolide for prostate cancer treatment. JAMA Netw Open. (Among 2226 men with advanced prostate cancer who initiated degarelix or leuprolide therapy between 2007 and 2019 who were propensity-matched for risk factors, major adverse cardiovascular event [MACE] rates were similar in the two groups [10.2 vs 8.6 per 100-patient years], although degarelix was associated with a high rate of death from any cause).
Lopes RD, Higano CS, Slovin SF, Nelson AJ, Bigelow R, Sørensen PS, Melloni C, et al., PRONOUNCE Study Investigators. (2021). Cardiovascular safety of degarelix versus leuprolide in patients with prostate cancer: the primary results of the PRONOUNCE randomized trial. Circulation. (Among 545 men with prostate cancer and concurrent atherosclerosis cardiovascular disease treated with degarelix or leuprolide for at least one year, major cardiovascular adverse events [MACE} arose in 5.5% vs 4.1% and rates of testosterone suppression, disease progression, discontinuations for adverse events and serious adverse event rates were similar in both groups).

## OTHER REFERENCE LINKS

1 Recent References on Degarelix: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Degarelix+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Degarelix: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Degarelix)